# Lorcaserin

## OVERVIEW

### Introduction

Lorcaserin is a selective serotonin agonist that was used as a weight loss agent. Lorcaserin was in clinical use for eight years when it was withdrawn because of concerns regarding an excess in cancer risk after long term use. In prelicensure studies and while in clinical use, lorcaserin was not found to be associated with serum enzyme elevations during therapy or to instances of clinically apparent liver injury.

### Background

Lorcaserin (lor ka' ser in) is a serotonin agonist that is relatively selective for the serotonin 2C (5-HT2C) receptor, that is located almost exclusively in the brain. Activation of this receptor activates pathways important in hunger and satiety, including those that induce proopiomelanocortin which decreases appetite. In several premarketing controlled trials, lorcaserin was found to lead to greater weight loss than placebo. Lorcaserin was officially approved for use in the United States in 2012, but was recommended only for patients who were obese (BMI ≥30) or who were overweight (BMI ≥27-30) and had a significant obesity related condition. In early 2020, lorcaserin was withdrawn from clinical use because of long term studies suggesting an increased risk of cancer with its use. Lorcaserin was available in 10 mg tablets under the commercial name Belviq. The recommended dose was 10 mg twice daily. An extended release formulation, available as 20 mg tablets (Belviq XR), was developed which allowed for once daily administration. Commonly reported side effects were headache, dry mouth, nausea, fatigue and dizziness which occasionally required discontinuation or dose adjustment. Severe side effects were rare and possibly included depression, serotonin syndrome and cardiac valvulopathy, although these side effects were not appreciably increased among lorcaserin treated patients in prelicensure clinical trials nor were they identified in subsequent postmarketing studies. A recent reanalysis of a large, long term trial of lorcaserin identified an excess incidence of cancer with treatment, including pancreatic, colorectal and lung cancer.

### Hepatotoxicity

In premarketing clinical trials, serum aminotransferase elevations were no more common among patients receiving lorcaserin than placebo. Clinically apparent liver injury due to lorcaserin has not been reported, but the numbers of patients treated has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Outcome and Management

No instances of acute liver failure or chronic liver injury have been linked to lorcaserin, but it has had limited general clinical use and now has been withdrawn because of an increased risk for cancer with long term use.

Drug Class: Weight Loss Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lorcaserin – Belviq®

DRUG CLASS

Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lorcaserin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lorcaserin | 616202-92-7 | C11-H14-CI-N

## ANNOTATED BIBLIOGRAPHY

References updated: 05 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999, well before the availability of lorcaserin).
Smith SR, Prosser WA, Donahue DJ, Morgan ME, Anderson CM, Shanahan WR, APD356-004 Study Group. (2009). Lorcaserin (APD356), a selective 5-HT (2C) agonist, reduces body weight in obese men and women. Obesity (Silver Spring). (Randomized controlled trial of 12 weeks of lorcaserin vs placebo in 469 obese subjects; no mention of ALT levels or hepatotoxicity).
Smith SR, Weissman NJ, Anderson CM, Sanchez M, Chuang E, Stubbe S, Bays H, Shanahan WR, Behavioral Modification and Lorcaserin for Overweight and Obesity Management (BLOOM) Study Group. (2010). Multicenter, placebo-controlled trial of lorcaserin for weight management. N Engl J Med. (Randomized controlled trial of 52 weeks of twice daily lorcaserin vs placebo in 3182 obese or overweight patients; serious adverse events included "hepatobiliary disorder" in 0.3% of lorcaserin and 0.3% of placebo recipient; no mention of ALT levels and no clinical details given).
Astrup A. (2010). Drug management of obesity--efficacy versus safety. N Engl J Med. (Editorial in response to Smith [2010] reviewing history of weight loss agents used in the United States, many having been withdrawn because of issues of safety of long term use).
Hurren KM, Berlie HD. (2011). Lorcaserin: an investigational serotonin 2C agonist for weight loss. Am J Health Syst Pharm. (Review of safety and efficacy of lorcaserin for weight loss based upon 3 phase III trials; most common side effects were nausea [8.3%], headache [16.8%], and dizziness [8.5%], but discontinuations for side effects were rare; no mention of ALT levels or hepatotoxicity).
Fidler MC, Sanchez M, Raether B, Weissman NJ, Smith SR, Shanahan WR, Anderson CM, BLOSSOM Clinical Trial Group. (2011). A one-year randomized trial of lorcaserin for weight loss in obese and overweight adults: the BLOSSOM trial. J Clin Endocrinol Metab. (Randomized controlled trial of two doses of lorcaserin vs placebo for an average of 20 weeks in 4008 obese or overweight patients: "No lorcaserin-associated changes in clinical laboratory parameters... were identified").
O'Neil PM, Smith SR, Weissman NJ, Fidler MC, Sanchez M, Zhang J, Raether B, et al. (2012). Randomized placebo-controlled clinical trial of lorcaserin for weight loss in type 2 diabetes mellitus: the BLOOM-DM study. Obesity (Silver Spring). (Randomized controlled trial of lorcaserin vs placebo in 604 overweight or obese patients with diabetes; no mention of ALT levels or hepatotoxicity).
Chan EW, He Y, Chui CS, Wong AY, Lau WC, Wong IC. (2013). Efficacy and safety of lorcaserin in obese adults: a meta-analysis of 1-year randomized controlled trials (RCTs) and narrative review on short-term RCTs. Obes Rev. (Systematic review of results from 5 randomized controlled trials of lorcaserin, only 3 of which used the agent for more than 12 weeks; no mention of hepatotoxicity or ALT elevations).
Nigro SC, Luon D, Baker WL. (2013). Lorcaserin: a novel serotonin 2C agonist for the treatment of obesity. Curr Med Res Opin. (Review of the mechanism of action, efficacy and safety of lorcaserin as therapy of obesity; no mention of liver injury or ALT elevations).
Yanovski SZ, Yanovski JA. (2014). Long-term drug treatment for obesity: a systematic and clinical review. JAMA. (Systematic review of the long term efficacy of drug therapies for obesity including lorcaserin, orlistat and phentermine plus topiramate).
(2014). Lorcaserin. In obesity: unacceptable risks. Prescrire Int. (Review of the efficacy and safety of lorcaserin concludes that its weight loss effects are minimal and short lived, and that its costs and risks of adverse events do not warrant its use as therapy of obesity).
Halpern B, Halpern A. (2015). Safety assessment of FDA-approved (orlistat and lorcaserin) anti-obesity medications. Expert Opin Drug Saf. (Review of the safety and efficacy of FDA approved medications for obesity including lorcaserin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none of the cases were attributed to a weight loss product such as lorcaserin).
Smith SR, Garvey WT, Greenway FL, Zhou S, Fain R, Pilson R, Fujioka K, et al. (2017). Coadministration of lorcaserin and phentermine for weight management: A 12-week, randomized, pilot safety study. Obesity (Silver Spring). (Among 235 overweight or obese, non-diabetic adults treated with lorcaserin alone or with phentermine [once or twice daily], weight loss was greater with the combination but so were side effects, but "there was no evidence of hepatic or renal toxicity").
Bohula EA, Scirica BM, Inzucchi SE, McGuire DK, Keech AC, Smith SR, Kanevsky E, et al., CAMELLIA-TIMI 61 Steering Committee Investigators. (2018). Effect of lorcaserin on prevention and remission of type 2 diabetes in overweight and obese patients (CAMELLIA-TIMI 61): a randomised, placebo-controlled trial. Lancet. (Among 12,000 overweight or obese adults treated with lorcaserin or placebo for a median of 3.3 years, weight loss was greater with lorcaserin by approximately 2.6 kg; no mention of ALT elevations or other adverse events).
Bohula EA, Wiviott SD, McGuire DK, Inzucchi SE, Kuder J, Im K, Fanola CL, et al., CAMELLIA–TIMI 61 Steering Committee and Investigators. (2018). Cardiovascular safety of lorcaserin in overweight or obese patients. N Engl J Med. (Further analysis of trial of lorcaserin in 12,000 overweight or obese adults focusing upon safety and adverse events mentions adverse events "possible" to include dizziness, fatigue, headache, diarrhea and nausea; no mention of ALT elevations or hepatotoxicity).
(2018). Diet, drugs, devices, and surgery for weight management. Med Lett Drugs Ther. (Concise review of the medical and surgical therapies for obesity mentions that lorcaserin is a schedule IV controlled substance and only modestly effective for weight loss and that adverse effects include headache, nausea, dizziness, euphoria and impairment of attention and cognition and possibly serotonin syndrome and cardiac valvulopathy; no mention of ALT elevations or hepatotoxicity).
Tuccinardi D, Farr OM, Upadhyay J, Oussaada SM, Mathew H, Paschou SA, Perakakis N, et al. (2019). Lorcaserin treatment decreases body weight and reduces cardiometabolic risk factors in obese adults: A six-month, randomized, placebo-controlled, double-blind clinical trial. Diabetes Obes Metab. (Among 48 obese adults treated with lorcaserin or placebo for 6 months, weight loss was greater with lorcaserin [-2 vs -0.4 kg] as were decreases in hepatic fat index, while ALT and AST levels were normal and remained normal with therapy).
Saunders KH, Umashanker D, Igel LI, Kumar RB, Aronne LJ. (2018). Obesity pharmacotherapy. Med Clin North Am. (Review of the pharmacotherapy of obesity focusing upon the 6 most commonly used medications, discusses the common side effects of lorcaserin including headache, dizziness, fatigue, nausea, dry mouth and constipation, but does not discuss hepatotoxicity).
Patel DK, Stanford FC. (2018). Safety and tolerability of new-generation anti-obesity medications: a narrative review. Postgrad Med. (Review of the history of approval and indications, efficacy and long term safety of major currently available weight loss agents including orlistat, phentermine/topiramate, lorcaserin, liraglutide and naltrexone/bupropion; does not discuss hepatotoxicity).
FDA. Information on Lorcaserin. 2020. Available at: https://www.fda.gov/media/135189/download (FDA letter requesting the voluntary withdrawal of lorcaserin because of a secondary analysis of the CAMELLIA-TIMI trial of lorcaserin vs placebo conducted between 2014 and 2018 in 12,000 adults followed for a median of 3.3 years that showed no differences in adverse cardiovascular outcomes, but an imbalance in incidence of cancers arising in 462 patients on lorcaserin [7.7%] vs 427 [7.1%] on placebo with imbalance with several specific forms including pancreatic, colorectal and lung [liver cancer not mentioned]).
Tak YJ, Lee SY. (2020). Anti-obesity drugs: long-term efficacy and safety: an updated review. World J Mens Health. (Review of currently available agents for long term therapy of obesity with specific discussion of mechanism of action, dosing regimen, efficacy and safety, mentions that phentermine/topiramate has the highest rates of weight loss compared to other agents, but also has a high rate of discontinuation because of side effects such as insomnia, paresthesia, dizziness, dry mouth, dysgeusia and constipation and has embryo-fetal toxicity; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Lorcaserin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lorcaserin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Lorcaserin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lorcaserin)